# Pilocarpine

## OVERVIEW

### Introduction

Pilocarpine is an orally available cholinergic agonist that is used to treat symptoms of dry mouth in patients with keratoconjunctivitis sicca (Sjögren syndrome) or with xerostomia (dry mouth) due to local irradiation. Pilocarpine has not been linked to serum enzyme elevations during therapy or to instances of clinically apparent liver injury.

### Background

Pilocarpine (pye" loe kar' peen) is a cholinergic agonist that stimulates muscarinic receptors, resulting in an increase in parasympathetic activity. Engagement of the cholinergic receptors causes increased secretion from exocrine glands, including sweat, salivary, lacrimal, gastric, pancreatic and intestinal glands, as well as increased tone and motility of smooth muscle cells in the eye, respiratory and gastrointestinal tract. Use of daily oral doses of pilocarpine has been shown to improve symptoms of dry mouth and increase salivary flow in patients with Sjögren syndrome and with xerostomia due to local irradiation therapy. Pilocarpine for oral use was approved for use in the United States in the 1990s and is currently available in generic forms as tablets of 5 mg. Pilocarpine is also available as ophthalmologic drops for therapy of glaucoma and ocular hypertension. The typical oral dose is 5 mg 2 to 4 times daily. Side effects are usually mild and largely attributable to cholinergic stimulation including increased sweating, rhinitis, nausea, diarrhea, headaches, dizziness, visual disturbances and fatigue.

### Hepatotoxicity

In clinical trials of pilocarpine, serum enzyme elevations were uncommon and no more frequent than with placebo. Despite, wide scale use, there have been no published reports of acute liver injury attributable to pilocarpine.

### Mechanism of Injury

The mechanism by which pilocarpine might cause serum aminotransferase elevations is not known. Pilocarpine is metabolized in parasympathetic synaptic clefts and in plasma and has little hepatic metabolism.

Drug Class: Sjögren Syndrome Agents, Cholinergic Agents

Other Drugs in the Class: Cevimeline

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pilocarpine – Generic

DRUG CLASS

Sjögren Syndrome Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Pilocarpine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Pilocarpine | 92-13-7 | C11-H16-N2-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 24 June 2020

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Extensive review of hepatotoxicity published in 1999; cholinergic agents and pilocarpine are not discussed).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Textbook of hepatotoxicity published in 2013; cholinergic agents and pilocarpine are not discussed).
Henderer JD, Rapuano CJ. Ocular pharmacology. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1251-70. (Textbook of pharmacology and therapeutics).
Fox PC, van der Ven PF, Baum BJ, Mandel ID. (1986). Pilocarpine for the treatment of xerostomia associated with salivary gland dysfunction. Oral Surg Oral Med Oral Pathol. (Pilot study of single doses of pilocarpine or placebo in 6 patients with Sjögren syndrome demonstrated an increase in salivary flow and decrease in sensation of dry mouth).
Rieke JW, Hafermann MD, Johnson JT, LeVeque FG, Iwamoto R, Steiger BW, Muscoplat C, Gallagher SC. (1995). Oral pilocarpine for radiation-induced xerostomia: integrated efficacy and safety results from two prospective randomized clinical trials. Int J Radiat Oncol Biol Phys. (Among 369 patients with xerostomia following cancer radiotherapy who were treated with pilocarpine [2.5-10 mg every 8 hours] or placebo for 12 weeks, there were no serious drug related adverse events at any dose).
Vivino FB, Al-Hashimi I, Khan Z, LeVeque FG, Salisbury PL, Tran-Johnson TK, Muscoplat CC, et al. (1999). Pilocarpine tablets for the treatment of dry mouth and dry eye symptoms in patients with Sjögren syndrome: a randomized, placebo-controlled, fixed-dose, multicenter trial. P92-01 Study Group. Arch Intern Med. (Among 373 patients with Sjögren syndrome who were treated with pilocarpine [2.5 or 5 mg 4 times daily] or placebo for 12 weeks, none had serious drug related adverse events; liver function tests were monitored, but there was no mention of ALT elevations or hepatotoxicity).
Wu CH, Hsieh SC, Lee KL, Li KJ, Lu MC, Yu CL. (2006). Pilocarpine hydrochloride for the treatment of xerostomia in patients with Sjögren syndrome in Taiwan--a double-blind, placebo-controlled trial. J Formos Med Assoc. (Among 44 patients with Sjögren syndrome treated with pilocarpine [5 mg 4 times daily] or placebo for 12 weeks, the most common side effect was excessive sweating [22%] and there were no serious adverse events or "significant alterations in ...hepatic profiles").
Fox RI. (2003). Sjogren's syndrome: evolving therapies. Expert Opin Investig Drugs. (Review of standard and experimental therapies of Sjögren syndrome mentions pilocarpine and cevimeline, but does not discuss its adverse side effects).
Papas AS, Sherrer YS, Charney M, Golden HE, Medsger TA, Walsh BT, Trivedi M, et al. (2004). Successful treatment of dry mouth and dry eye symptoms in Sjögren syndrome patients with oral pilocarpine: a randomized, placebo-controlled, dose-adjustment study. J Clin Rheumatol. (Among 250 patients with Sjögren syndrome treated with pilocarpine [20-30 mg daily] or placebo for 12 weeks, there were no serious drug related adverse events or significant changes in laboratory results in comparison to placebo).
Berk L. (2008). Systemic pilocarpine for treatment of xerostomia. Expert Opin Drug Metab Toxicol. (Review of 6 controlled trials of pilocarpine for radiation induced xerostomia; among 261 patients treated long term, side effects included sweating [55%], urinary frequency [11%], rhinitis [10%], headache [8%], increased lacrimation [8%] and diarrhea [6%], with no mention of ALT elevations or clinically apparent liver injury).
Ramos-Casals M, Tzioufas AG, Stone JH, Sisó Bosch X. (2010). Treatment of primary Sjögren syndrome: a systematic review. JAMA. (Review of 3 controlled trials of pilocarpine in 673 patients with Sjögren syndrome found improvements in symptoms of dry mouth and dry eyes with a dose of 5 mg every 6 hours, but also a higher rate of excessive sweating, urinary frequency and nausea; no mention of ALT elevations or clinically apparent liver injury).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were linked to pilocarpine or other cholinergic agents).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: the DILIN prospective study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no cases were attributed to pilocarpine or other cholinergic agents).
Tanigawa T, Yamashita J, Sato T, Shinohara A, Shibata R, Ueda H, Sasaki H. (2015). Efficacy and safety of pilocarpine mouthwash in elderly patients with xerostomia. Spec Care Dentist. (Among 40 elderly patients with dry mouth who were treated with pilocarpine or plain water mouthwash for 4 weeks, drop outs were frequent, and common side effects were oral or tongue discomfort, while xerostomia improved with the pilocarpine but not the water mouthwash).
Brito-Zerón P, Retamozo S, Kostov B, Baldini C, Bootsma H, De Vita S, Dörner T, et al. (2019). Efficacy and safety of topical and systemic medications: a systematic literature review informing the EULAR recommendations for the management of Sjögren's syndrome. RMD Open. (Systematic review of the literature on therapies for sicca syndrome mentions 5 controlled trials showing improvements in oral dryness and saliva flow with pilocarpine and cevimeline but no evidence for effects from trials of systemic treatments with anakinra, hydroxychloroquine, infliximab or rituximab).

## OTHER REFERENCE LINKS

1 Recent References on Pilocarpine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Pilocarpine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Pilocarpine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Pilocarpine)